# Gepotidacin

## OVERVIEW

### Introduction

Gepotidacin is a unique and recently approved antibiotic used for oral treatment of uncomplicated urinary tract infections and urogenital gonorrhea. Gepotidacin therapy is given in short courses of 1 or 5 days and has not been associated with elevations in serum aminotransferase levels or clinically apparent liver injury.

### Background

Gepotidacin (jep” oh ti day’ sin) is a triazaacenaphthylene antibiotic that is used to treat uncomplicated urinary tract infections in women and uncomplicated urogenital gonorrheal in persons 12 years of age or older. Its mechanism of action is by inhibition of two bacterial type II topoisomerase enzymes (gyrase and topoisomerase, type IV) which blocks bacterial DNA replication. Gepotidacin is considered bacteriocidal and is a “first-in-class” antibiotic. It has activity against many gram positive and negative organisms including Neisseria gonorrhea, Escherichia coli, Klebsiella pneumoniae, Proteus mirabilis, Citrobacter freundii, Staphylococcus saprophyticus, and Enterococcus faecalis. Gepotidacin was approved in the United States as therapy of uncomplicated urinary tract infections in women in 2025 and later in the same year for urogenital gonorrhea in both men and women above the age of 12 years. Gepotidacin is available under the brand name Blujepa in tablets of 750 mg. The recommended dose for gonorrhea is 3 gm (4 tablets) orally twice on a single day (10 to 12 hours apart), and for urinary tract infections is 1.5 gm (2 tablets) twice a day for 5 days. Common side effects include diarrhea, nausea, abdominal discomfort, and flatulence. Less common adverse events can be caused by effects of its inhibition of acetylcholinesterase which can lead to dysarthria, fainting, muscular spasms, nausea and vomiting, diarrhea, hypersalivation, and sweating. Side effects of gepotidacin are common, but usually mild to moderate in severity and transient in duration. Rare but potentially severe adverse events include hypersensitivity reactions, including anaphylaxis, Clostridioides difficile diarrhea, syncope, and bradycardia.

### Hepatotoxicity

In pre-registration clinical trials, serum aminotransferase and alkaline phosphatase elevations were no more frequent in patients receiving gepotidacin than in those receiving comparator antibiotics (nitrofurantoin or ceftriazone and azithromycin). Serum aminotransferase elevations above 3 times the upper limit of normal (ULN) arose in 1% and above 5 times the ULN in 0.1% of patients and were not accompanied by symptoms or jaundice. Furthermore, there have been no case reports of clinically apparent liver injury attributed to gepotidacin since its approval and more wide scale use.

Likelihood score: E (unlikely cause of clinically apparent liver injury).

### Mechanism of Injury

The mechanism by which gepotidacin might cause liver injury is not known. It is typically given for 1 or 5 days only although in high doses. Longer courses of therapy may increase risks of hepatotoxicity or other unwanted adverse side effects.

### Outcome and Management

The serum aminotransferase elevations that occur on gepotidacin therapy are usually self-limited and rarely require dose modification or discontinuation . However, persistent ALT or AST elevations above 3 times the upper limit of the normal range (ULN) should lead to dose adjustment or discontinuation. Any ALT elevation above 10 times the ULN or ALT elevations with symptoms or jaundice should lead to immediate discontinuation.

Drug Class: Antiinfective Agents; Antibacterial Agents

Other Drugs in the Subclass: Zoliflodacin

## PRODUCT INFORMATION

REPRESENTATIVE TRADE NAMES

Gepotidacin – Blujepa®

DRUG CLASS

Antibiotics, Triazaacenaphthylene

COMPLETE LABELING (https://dailymed.nlm.nih.gov/dailymed/search.cfm?labeltype=all&query=gepotidacin)

Product labeling at DailyMed, National Library of Medicine, NIH

## CHEMICAL FORMULA AND STRUCTURE

DRUG | CAS REGISTRY NUMBER | MOLECULAR FORMULA | STRUCTURE
Gepotidacin | 1075236-89-3 | C24H28N6O3

ANNOTATED BIBLIOGRAPHY

References updated: 15 March 2026

Abbreviations used: ULN, upper limit of normal

Zimmerman HJ. Hepatotoxicity: the adverse effects of drugs and other chemicals on the liver. 2nd ed. Philadelphia: Lippincott, 1999. (Expert review of hepatotoxicity of antibiotics published in 1999, before the availability of gepotidacin).
MacDougall C. Protein synthesis inhibitors and miscellaneous antibacterial agents. In, Brunton LL, Hilal-Dandan R, Knollman KC, eds. Goodman & Gilman’s the pharmacological basis of therapeutics. 13th ed. New York: McGraw-Hill, 2018, pp. 1049-65. (Textbook of pharmacology and therapeutics, published before the availability of gepotidacin).
https://www.accessdata.fda.gov/drugsatfda_docs/nda/2025/218230Orig1s000TOC.html (FDA website with product label and FDA reviews of efficacy and safety of gepotidacin, based upon data submitted by the sponsor in support of its approval as therapy for urinary tract infections, mentions that elevations in ALT, AST, Alk P and bilirubin were similar with gepotidacin to with nitrofurantoin, ALT above 3 times ULN in 0.9% vs 1.2%, and above 5 times ULN in 0.1% vs 0.3%, none of the ALT elevations were accompanied by bilirubin elevations; in a controlled trial of gepotidacin vs ceftriaxone plus azithromycin in patients with gonorrhea, rates of liver test abnormalities were similar in both arms, ALT elevations above 3 times ULN arising in 0.7% vs 0.3% [2 vs 1 participant] and none with accompanying jaundice or symptoms).
Wagenlehner F, Perry CR, Hooton TM, Scangarella-Oman NE, Millns H, Powell M, Jarvis E, et al. Oral gepotidacin versus nitrofurantoin in patients with uncomplicated urinary tract infection (EAGLE-2 and EAGLE-3): two randomised, controlled, double-blind, double-dummy, phase 3, non-inferiority trials. Lancet. 2024;403(10428):741-755.. (Among 3136 women [ages 12 years or more] with symptomatic urinary tract infections treated with gepotidacin [1.5 gm] or nitrofurantoin [100 mg] twice daily for 5 days in two controlled trials, microbiologic cure was achieved in 54% vs 45% [non-inferior] and adverse events arose in 35% vs 23%], but most were mild or moderate, and severe adverse events arose in less than 1% of both groups; no mention of ALT elevations or hepatotoxicity). 38342126
Ross JDC, Wilson J, Workowski KA, Taylor SN, Lewis DA, Gatsi S, Flight W, et al. Oral gepotidacin for the treatment of uncomplicated urogenital gonorrhea (EAGLE-1): a phase 3 randomised, open-label, non-inferiority, multicentre study. Lancet. 2025;405(10489):1608-1620.. (Among 628 patients [age 12 years and above] treated with gepotidacin [3 gm twice by mouth, 10 to 12 hours apart] vs ceftriaxone [500 mg im once] combined with azithromycin [1 gm once by mouth] cure rates were 93% vs 91% [non-inferior] while adverse events arose in 74% vs 33% which were all mild to moderate in severity and included diarrhea [49% vs 10%], nausea [24% vs 3%]; no mention of ALT elevations or hepatotoxicity). 40245902
Keam SJ. Gepotidacin: first approval. Drugs. 2025;85:1479-1485. (Summary of the mechanism of action, history of development, pharmacology, clinical efficacy, and safety of gepotidacin mentions that adverse events were mostly mild-to-moderate and serious adverse effects arose in less than 1%; no mention of ALT elevations or hepatotoxicity). 40762778
Scangarella-Oman NE, Butler DL, Breton J, Brown D, Kasapidis C, Millns H, Huang C, et al. Efficacy and in vitro activity of gepotidacin against bacterial uropathogens, including drug-resistant phenotypes, in females with uncomplicated urinary tract infections: results from two global, pivotal, phase 3 trials (EAGLE-2 and EAGLE-3). Antimicrob Agents Chemother. 2025;69:e0164024. (Complete analysis of the two randomized, comparator arm controlled trials of gepotidacin as therapy of uncomplicated urinary tract infections in women does not mention adverse events). 40924001
Gepotidacin (Blujepa) - a new antibiotic for uncomplicated UTI. Med Lett Drugs Ther. 2026;68(1745):1-3. PMID: . (Concise review of the mechanism of action, clinical efficacy, safety, and costs of gepotidacin shortly after its approval in the United States as therapy of uncomplicated urinary tract infections in women; does not mention ALT elevations or hepatotoxicity). 41505597
Two new drugs for gonorrhea. Med Lett Drugs Ther. 2026;68(1750):41-43. (Concise review of the mechanism of action, clinical efficacy, safety, and costs of gepotidacin shortly after its approval in the United States as therapy of uncomplicated urogenital gonorrhea; does not mention ALT elevations or hepatotoxicity). 41793382

## OTHER REFERENCE LINKS

1. Recent References on Gepotidacin: from PubMed.gov (https://www.ncbi.nlm.nih.gov/sites/entrez?cmd=search&db=pubmed&pubmedfilters=true&term=(gepotidacin%20AND%20anti-bacterial%20agents)%20AND%20Human%5bMesh%5d%20AND%20(jaundice%20OR%20bile%20duct%20diseases%20OR%20liver%20OR%20liver%20diseases%20OR%20hepatitis,%20toxic%5bMesh%5d)%20AND%20(%222009/1/1%22%5bEDat%5d:%222999/12/31%22%5bEDat%5d))

2. Trials on Gepotidacin: from ClinicalTrials.gov (https://clinicaltrials.gov/ct2/results?term=Gepotidacin)